# Teprotumumab

## OVERVIEW

### Introduction

Teprotumumab is a human monoclonal antibody to the insulin-like growth factor 1 receptor which is used to treat the ophthalmopathy of Graves disease. Teprotumumab is generally well tolerated and has not been associated with serum aminotransferase elevations during therapy or with instances of clinically apparent liver injury.

### Background

Teprotumumab (tep” roe toom’ ue mab) is a human IgG1 monoclonal antibody directed against the insulin-like growth factor 1 receptor (IGF1R) that is used in the therapy of Graves ophthalmopathy (thyroid eye disease). Graves disease is an autoimmune disease associated with autoantibodies, hyperthyroidism and a distinctive form of eye disease marked by ocular inflammation and proptosis causing eye pain, dryness, redness, and swelling which if severe can cause diplopia (double-vision) and loss of vision. Graves ophthalmopathy is associated with autoantibodies to thyrotropin and hypertrophy of ocular fibroblasts which overexpress the IGF1 receptor. Teprotumumab causes inhibition of IGF1 binding to its receptor and preventing cell activation. IGF1 is a potent modulator of cell growth and inhibitor of programmed cell death, acting via the PI3K-AKT-mTOR pathway. The inhibition of IGF1 signaling decreases fibroblast proliferation and hypertrophy. In two randomized, placebo-controlled trials, a four month course of teprotumumab infusions led to clinical improvement in proptosis in 71% to 83% of patients compared to 10% to 20% with placebo infusions. Teprotumumab was approved as therapy of Graves ophthalmopathy in the United States in 2019, the first therapy approved specifically for this indication. Previously, only partially effective and off-label therapies for Graves ophthalmopathy were available, including weekly infusions of high doses of methylprednisolone as well as other immunomodulatory agents such as mycophenolate, azathioprine, tocilizumab, and rituximab. Teprotumumab is available as a powder for resuspension in single use vials of 500 mg under the brand name Tepezza. The recommended dose of teprotumumab is 10 mg/kg intravenously initially followed by 20 mg/kg every 3 weeks for a total of 8 doses. Common side effects include local infusion reactions, muscle spasms, nausea, diarrhea, alopecia, hyperglycemia and fatigue. Rare but potentially severe adverse reactions include exacerbation of inflammatory bowel disease, hearing loss and cognitive decline. Teprotumumab also is embryotoxic, and women of child bearing potential need to use effective means of contraceptive measures before and during therapy and for 6 months thereafter.

### Hepatotoxicity

In preregistration trials of teprotumumab, abnormalities in serum aminotransferase levels were not reported. Furthermore, there were no reported hepatic serious adverse events or mention of clinically apparent liver injury. Since approval and more general use of teprotumumab there have been no reports of clinically significant liver injury attributed to its use. However, teprotumumab has had limited clinical use and its overall safety, particularly if given in more than one course, is not fully defined.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to teprotumumab are not known. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids. On the other hand, IGF1 receptors are wide spread and have important functions in growth and development and may alter normal metabolic pathways that can affect liver function or underlying liver conditions.

### Outcome and Management

Drug Class: Monoclonal Antibodies, Antithyroid Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Teprotumumab – Tepezza®

DRUG CLASS

Antithyroid Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Teprotumumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Teprotumumab | 1036734-93-6 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 July 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of teprotumumab).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/761143Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the teprotumumab application which mentions that “no significant shifts in laboratory findings were noted”).
Ramalingam SS, Spigel DR, Chen D, Steins MB, Engelman JA, Schneider CP, Novello S, et al. (2011). Randomized phase II study of erlotinib in combination with placebo or R1507, a monoclonal antibody to insulin-like growth factor-1 receptor, for advanced-stage non-small-cell lung cancer. J Clin Oncol. (Among 172 patients with advanced non-small cell lung cancer treated with erlotinib with or without teprotumumab [R1507] in doses of 9 or 16 mg/kg once every 3 weeks, overall response rates were similar in all three groups [7% to 9%], while side effects more common in those receiving teprotumumab included deep vein thromboses [8%vs 0], fatigue, skin rash and discontinuations because of adverse reactions [6% vs 3.5%], no mention of ALT elevations or hepatotoxicity).
Pappo AS, Vassal G, Crowley JJ, Bolejack V, Hogendoorn PC, Chugh R, Ladanyi M, et al. (2014). A phase 2 trial of R1507, a monoclonal antibody to the insulin-like growth factor-1 receptor (IGF-1R), in patients with recurrent or refractory rhabdomyosarcoma, osteosarcoma, synovial sarcoma, and other soft tissue sarcomas: results of a Sarcoma Alliance for Research Through Collaboration study. Cancer. (Among 163 patients with recurrent or refractory malignant sarcomas who were treated with teprotumumab [R1507] in a dose of 9 mg/kg intravenously once weekly, the overall response rate was only 2.5% and the most common adverse reactions were fatigue [20%], nausea [14%], hyperglycemia [9%], and muscle spasms [9%]), and one patient [<1%] had serum ALT elevations above 5 times ULN).
Ma H, Zhang T, Shen H, Cao H, Du J. (2014). The adverse events profile of anti-IGF-1R monoclonal antibodies in cancer therapy. Br J Clin Pharmacol. (Systematic review of the literature found 15 articles that reported adverse events of anti-IGF1R monoclonal antibodies used in cancer chemotherapy that collectively reported fatigue in [29%], skin rash [20%], nausea [18%], hyperglycemia [15%] and ALT or AST elevations [8%], but the liver enzyme elevations occurred with cixutumumab [8%] and figitumumab [13%] and not teprotumumab).
Smith TJ, Hegedüs L. (2016). Graves' Disease. N Engl J Med. (Review of the clinical features, pathogenesis, diagnosis, natural history and management of Graves disease including discussion of Graves ophthalmopathy and the possible role of IGF1 signaling its pathogenesis).
Smith TJ, Kahaly GJ, Ezra DG, Fleming JC, Dailey RA, Tang RA, Harris GJ, et al. (2017). Teprotumumab for thyroid-associated ophthalmopathy. N Engl J Med. (Among 88 patients with recent onset of Graves ophthalmopathy treated with 8 three-weekly infusions of teprotumumab or placebo, clinical responses occurred by 24 weeks in 43% vs 4% while adverse events included nausea [19% vs 9%], muscle spasms [19% vs 5%], diarrhea, hyperglycemia [12% vs 5%], alopecia, dry skin, paresthesias and hearing loss [7% vs 0%]; no mention of ALT elevations or hepatotoxicity).
Taylor PN, Zhang L, Lee RWJ, Muller I, Ezra DG, Dayan CM, Kahaly GJ, et al. (2020). New insights into the pathogenesis and nonsurgical management of Graves orbitopathy. Nat Rev Endocrinol. (Review of the pathogenesis of Graves ophthalmopathy and role of thyrotropin and IGF1 signaling and discussion of therapies, including teprotumumab).
Douglas RS, Kahaly GJ, Patel A, Sile S, Thompson EHZ, Perdok R, Fleming JC, et al. (2020). Teprotumumab for the treatment of active thyroid eye disease. N Engl J Med. (Among 81 patients with Graves ophthalmopathy treated with teprotumumab or placebo, clinical improvement was achieved in 83% vs 10% and most adverse events were mild-to-moderate, including muscle spasms [32% vs 10%], alopecia, nausea, weight loss and hearing loss [12% vs 0]; there was one severe infusion reaction, one patient developed IBD; no mention of ALT elevations or hepatotoxicity).
Markham A. (2020). Teprotumumab: first approval. Drugs. (Review of the mechanism of action, development, pharmacology, clinical efficacy and safety of teprotumumab shortly after its approval as therapy of Graves eye disease in the US mentions adverse reactions of muscle spasms [25% vs 7% in controls], nausea [17% vs 9%], alopecia [13% vs 8%], diarrhea [12% vs 8%], fatigue [12% vs 7%], hyperglycemia [10% vs 1%] and hearing loss [10% vs 0], but does not mention ALT elevations or hepatotoxicity).
Ashraf DC, Jankovic I, El-Nachef N, Winn BJ, Kim GE, Kersten RC. New-onset of inflammatory bowel disease in a patient treated with teprotumumab for thyroid associated ophthalmopathy. Ophthalmic Plast Reconstr Surg 2021 Mar 8. Epub ahead of print. (45 year old woman with Graves ophthalmopathy developed symptoms of inflammatory bowel disease [IBD] after a sixth infusion of teprotumumab, which did not resolve on stopping and ultimately required hospitalization, corticosterol, methotrexate and rituximab).
Bednarczuk T, Pearce SH. (2021). The knowns and unknowns of teprotumumab for thyroid eye disease. Lancet Diabetes Endocrinol. (Editorial on Kahaly [{2021] with overview of Graves ophthalmopathy marked by autoimmune induced inflammation and hypertrophy of periorbital connective tissue and muscle cells which overexpress IGF1 and respond to inhibition of IGF1 receptors and pointing out the need for further studies and follow up of teprotumumab therapy for maintenance of response and long-term safety).
Kahaly GJ, Douglas RS, Holt RJ, Sile S, Smith TJ. (2021). Teprotumumab for patients with active thyroid eye disease: a pooled data analysis, subgroup analyses, and off-treatment follow-up results from two randomised, double-masked, placebo-controlled, multicentre trials. Lancet Diabetes Endocrinol. (Combined analysis and follow up of 2 randomized, placebo-controlled trials of teprotumumab in 171 patients with recent onset, moderate-to-severe Graves ophthalmopathy reporting overall proptosis responses in 77% of teprotumumab vs 15% of placebo recipients and similar differences in clinical activity and double vision response, which were largely maintained in a further 6 months of follow up, while no new adverse events arose and most that occurred during therapy subsequently resolved).
Hoang TD, Nguyen NT, Chou E, Shakir MK. (2021). Rapidly progressive cognitive decline associated with teprotumumab in thyroid eye disease. BMJ Case Rep. (76 year old man with Graves ophthalmopathy developed onset of confusion and progressive cognitive decline after a 4^th^ infusion of teprotumumab, which did not improve on stopping until he underwent plasmapheresis).
Belinsky I, Creighton FX Jr, Mahoney N, Petris CK, Callahan AB, Campbell AA, Kazim M, et al. Teprotumumab and hearing loss: case series and proposal for audiologic monitoring. Ophthalmic Plast Reconstr Surg 2021 Jun 4. Epub ahead of print. (Case reports of 4 patients with Graves ophthalmopathy who developed hearing loss during therapy with teprotumumab including 4 women, ages 34 to 77 years, developing largely high frequency neurosensory hearing loss after 3 to 8 infusions, persisting during short term follow up).
(2021). Teprotumumab (Tepezza) for thyroid eye disease. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of teprotumumab shortly after its approval for use in the US mentions common adverse events but does not mention ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Teprotumumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Teprotumumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Teprotumumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Teprotumumab)